# Aloe Vera

## OVERVIEW

### Introduction

Aloe vera is a cactus-like plant belonging to the Lily family, extracts of which are used topically for skin care and orally as a component of many herbal mixtures claimed to have medicinal benefits. Oral forms of aloe vera have been linked to rare instances of clinically apparent liver injury.

### Background

Aloe vera (“true, shining bitter substance”) is derived from a cactus-like plant, a member of the Lily family that grows best in arid climates. Aloe vera has been used for centuries for its purported healing properties. Aloe vera products are derived from the leaf (either the gel or leaf rind latex) and contain over 75 identified substances including anthraquinones (phenolic compounds with laxative actions), vitamins (A, C, E), enzymes (aliiase, alkaline phosphatase, amylase, bradykinase, carboxypeptidase, catalase, cellulose, lipase, and peroxidase), minerals, sugars, fatty acids, amino acids, salicylic acid and hormones (auxins and gibberellins suspected to have antiinflammatory activity). Aloe creams are found in hundreds of skin products used for cosmetic purposes and wound healing. Extracts and powdered extracts from leaf rind latex of aloe vera are used in small amounts as a food flavoring and in larger amounts in dietary supplements. In addition, aloe vera is claimed to have beneficial effects on arthritis, asthma, chronic fatigue, dyspepsia, constipation and various skin ailments. Recently, it has also been claimed to be helpful in weight loss. The bases of these claims have not been substantiated, but in vitro and animal studies suggest that components of aloe vera have antiproliferative, antiinflammatory, and hepato-protective properties. Aloe vera is generally tolerated without adverse events; minor side effects may include diarrhea, abdominal discomfort and nausea. Chronic use for constipation can lead to discoloration of the colon (pseudo-melanosis coli). Rare instances of hypersensitivity reactions, skin rash and allergic dermatitis have been described.

### Hepatotoxicity

Liver injury attributable to oral preparations of aloe vera was first reported in 2005 and at least a dozen cases of clinically apparent liver injury have been published or mentioned in the literature. The injury typically arises between 3 and 24 weeks after starting oral aloe vera, usually provided in high doses to treat constipation, dyspepsia, aging, weight loss or to improve wellness. The typical pattern of injury is hepatocellular and the clinical course resembles acute viral hepatitis (Case 1). Immunoallergic and autoimmune features are rare. Liver biopsy shows changes typical of hepatitis with spotty cell injury and lobular and portal inflammation. The injury is rarely severe and fatal cases have not been reported.

Likelihood score: B (likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

Aloe vera leaf extracts have many components, but none of them has been shown to be particularly hepatotoxic. The rare cases of liver injury reported with aloe vera use have had idiosyncratic features.

### Outcome and Management

Hepatotoxicity from aloe vera is rare and cases have been self-limiting upon stopping the herbal. While some reported cases have been severe or prolonged, there have been no instances leading to fatalities, liver transplantation, chronic hepatitis, or vanishing bile duct syndrome. Rechallenge has led to recurrence of injury in at least one published case report (Case 2) and should be avoided.

Drug Class: Herbal and Dietary Supplements

## CASE REPORTS

### Case 1. Acute hepatitis due to aloe vera extract.(1)

A 57 year old German woman developed jaundice, itching and right upper quadrant pain 3 to 4 weeks after starting aloe vera tablets (500 mg daily), which she was taking for aging. She also was taking vitamin C and zinc, but no other prescription medications. She denied a history of liver disease, alcohol use or risk factors for viral hepatitis. On examination, she was jaundiced and had right upper quadrant tenderness, but no rash, fever or signs of chronic liver disease. Laboratory testing showed increased bilirubin values (8.9 mg/dL) and marked elevations in serum aminotransferase levels (ALT 1480 U/L, AST 711 U/L), with minimal increase in alkaline phosphatase (265 U/L) (Table). Tests for acute hepatitis A, B, C and E were negative. Serum antinuclear antibody was borderline positive (titer 1:40). Abdominal ultrasound showed no evidence of biliary obstruction. A liver biopsy showed an acute hepatitis, with portal and parenchymal infiltrates including plasma cells and eosinophils and bridging necrosis with cholestasis. The aloe vera was stopped and her symptoms rapidly resolved. The biochemical abnormalities resolved more slowly; serum enzymes were still elevated 5 months later but were near normal at one year.

#### Key Points

Medication: | Aloe vera (500 mg daily)
Pattern: | Hepatocellular (R=39)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 weeks
Recovery: | 6 months
Other medications: | Vitamin C, zinc

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
| | Aloe vera tablets 500 mg daily for 4 weeks
4 weeks | 0 | 1480 | 265 | 8.9 | Admission, liver biopsy
6 weeks | 2 weeks | 226 | | | Discharge
6 months | 5 months | 180 | | Normal | Asymptomatic
1 year | 12 months | 40 | | Normal
Normal Values | | <22 | <160 | <1.2

#### Comment

This was the first published report of hepatitis from aloe vera. An elderly woman with no exposures to viral hepatitis or other reasons to have liver disease developed an acute hepatitis-like syndrome after taking an oral aloe vera extract for a month. Most other causes of acute hepatitis were adequately excluded. A liver biopsy showed an acute hepatitis with cholestasis and eosinophils suggestive of a drug induced liver injury. Biochemical recovery was somewhat prolonged. While there did not appear to be other possible causes for liver injury in this case, the issue of possible contamination is always present and the aloe vera product being used had been purchased outside of Germany.

### Case 2. Recurrent acute hepatitis due to aloe vera.(2)

A 62 year old Korean woman developed fatigue followed by jaundice 3 months after starting an aloe vera powder (420 mg daily). There was no history of liver disease or alcoholism. Laboratory test results showed a serum total bilirubin of 14.6 mg/dL with marked elevations in serum aminotransferase levels (ALT 1564 U/L, AST 1477 U/L), but minimal increases in alkaline phosphatase (211 U/L) (Table). Tests for hepatitis A, B, C and E were negative. Abdominal ultrasound showed no evidence of biliary obstruction. A liver biopsy showed changes of acute hepatitis with lobular and portal infiltrates and cholestasis. The aloe vera was stopped and after a week she began to improve. Six weeks after stopping the herbal, liver tests were close to normal. During subsequent follow up, however, she restarted an aloe vera extract and a month later serum ALT values were again elevated (785 U/L), although bilirubin was normal. Six months later she returned with jaundice (bilirubin 15.8 mg/dL, ALT 1135 U/L, alkaline phosphatase 243 U/L), but refused admission or further evaluation.

#### Key Points

Medication: | Aloe vera (420 mg daily)
Pattern: | Hepatocellular (R=32)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 months initially, 1 month on reexposure
Recovery: | Approximately 6 weeks; relapse on reexposure
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
| | Aloe vera 420 mg daily for ~3 months
12 weeks | 0 | 1564 | 211 | 14.6 | Admission
13 weeks | 1 week | 1504 | 202 | 21.2 | Liver biopsy
14 weeks | 2 weeks | 754 | 176 | 5.8
15 weeks | 3 weeks | 425 | 163 | 4.5
16 weeks | 4 weeks | 135 | 110 | 3.4
18 weeks | 6 weeks | 21 | 110 | 2.1
| | Aloe vera 420 mg daily, restarted for 1 month
4 weeks | 0 | 785 | 165 | 1.5
Normal Values | | <33 | <160 | <1.2

#### Comment

This is one of the better documented cases of acute liver injury due to an aloe vera product in the literature. The latency to onset was 3 months initially and the patient developed fairly severe jaundice. Serum aminotransferase levels were quite high and the pattern of injury was clearly hepatocellular. A week after the aloe vera was stopped, liver tests began to improve and they were almost normal 6 weeks later. This patient was an herbal salesperson and restarted the aloe vera on her own, despite having been told that it probably caused the liver injury. The latency on reexposure was only one month, although the injury was somewhat less severe, with enzyme elevations without jaundice. However, six months later she returned with jaundice and a similar pattern of serum enzyme elevations, but refused further evaluation. While recurrent toxic hepatitis due to reexposure was the most likely diagnosis, the other possibility was a relapsing, acute onset of autoimmune hepatitis.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Aloe Vera – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/aloevera)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Aloe Vera | 8001-97-6 | Herbal | Not Applicable

## CITED REFERENCES

1 Rabe C, Musch A, Schirmacher P, Kruis W, Hoffmann R. (2005). Acute hepatitis induced by an aloe vera preparation: A case report. World J Gastroenterol.
2 Yang HN, Kim DJ, Kim YM, Kim BH, Sohn KM, Choi MJ, Choi YH. (2010). Aloe-induced toxic hepatitis. J Korean Med Sci.

## ANNOTATED BIBLIOGRAPHY

References updated: 24 May 2022

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not aloe vera).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; mentions that aloe vera is generally nonhepatotoxic).
Aloe. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 19-26. (Compilation of short monographs on herbal medications and dietary supplements).
Vogler BK, Ernst E. (1999). Aloe vera: a systematic review of its clinical effectiveness. Br J Gen Pract. (Systematic review of the literature on aloe vera identified 3 controlled trials of oral therapy for short periods in hyperlipidemia and diabetes found only mild and reversible adverse events and no mention of hepatotoxicity).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury due to herbals, including discussion of potential risk factors, and herb-drug interactions).
Luyckx VA, Ballantine R, Claeys M, Cuyckens F, Van den Heuvel H, Cimanga RK, Vlietinck AJ, et al. (2002). Herbal remedy-associated acute renal failure secondary to Cape aloes. Am J Kidney Dis. (47 year old man presented with acute renal failure and serum enzyme elevations [ALT 713 U/L, AST 2034 U/L, Alk P 74 U/L, bilirubin 0.6 mg/dL], having taken herbal medications for digestive complaints; mass spectrometry of herbal revealed it to be an extract of Aloe capensis).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity, including common patterns of presentation).
Pittler MH, Ernest E. (2003). Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 52 case reports or case series, most common agents being celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma huang [3], pennyroyal [1], skullcap [2], Chinese herbs [9], valerian [1]).
Estes JD, Stolpman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. (2003). High prevalence of potentially hepatotoxic herbal supplement use in patients with fulminant hepatic failure. Arch Surg. (Among 20 patients undergoing liver transplantation for acute liver failure during 2001-2, 10 were potentially caused by herbals, but none attributed to aloe vera).
Langmead L, Feakins RM, Goldthorpe S, Holt H, Tsironi E, De Silva A, Jewell DP, et al. (2004). Randomized, double-blind, placebo-controlled trial of oral aloe vera gel for active ulcerative colitis. Aliment Pharmacol Ther. (Randomized controlled trial of 4 week course of aloe vera vs placebo in 44 patients with ulcerative colitis found improvements in clinical scores with aloe vera; adverse side effects were minor and similar in the two groups, and “no patient developed abnormal blood tests attributable to aloe vera”).
Can A, Akev N, Ozsoy N, Bolkent S, Arda BP, Yanardag R, Okyar A. (2004). Effect of aloe vera leaf gel and pulp extracts on the liver in type-II diabetic rat models. Biol Pharm Bull. (In animal models exposed to stress, aloe vera appeared to attenuate liver injury attributable to diabetes).
Rabe C, Musch A, Schirmacher P, Kruis W, Hoffmann R. (2005). Acute hepatitis induced by an aloe vera preparation: A case report. World J Gastroenterol. (57 year old German woman developed jaundice and itching 1 month after starting aloe vera [500 mg/day] [bilirubin 8.9 mg/dL, ALT 1480 U/L, Alk P 265 U/L], resolving slowly: Case 1).
Kanat O, Ozet A, Ataergin S. (2006). Aloe vera-induced acute toxic hepatitis in a healthy young man. Eur J Intern Med. (24 year old man developed jaundice 3 weeks after starting aloe vera [500 mg by mouth daily] [bilirubin 9 mg/dL, ALT 2400 U/L, Alk P 400 U/L], resolving within 6 weeks of stopping).
Bottenberg MM, Wall GC, Harvey RL, Habib S. (2007). Oral aloe vera-induced hepatitis. Ann Pharmacother. (73 year old woman developed jaundice having taking aloe vera capsules for constipation for five years [bilirubin 10.7 rising to 22.8 mg/dL, ALT 1451 U/L, Alk P 328 U/L, SMA 1:160], with normal ERCP and liver biopsy showing acute hepatitis, resolving within 4 months of stopping).
Seeff LB. (2007). Herbal hepatotoxicity. Clin Liver Dis. (Review of herbal induced hepatotoxicity, with details on specific herbal compounds).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but no case was attributed to aloe vera alone or in combination with other agents).
Belfrage B, Malmstrom R. (2008). Lakartidningen. (Reports of liver injury due to aloe vera include 4 in the Swedish database [2 hepatitis, 1 jaundice and 1 enzyme elevations only, arising within 3 months after starting and resolving on stopping] and 5 in the international database [2 hepatitis and 3 with enzyme elevations only]).
Curciarello J, De Ortuzar S, Borzi S, Bosia D. (2008). Gastroenterol Hepatol. (26 year old man developed abdominal pain followed by jaundice 4 weeks after starting homemade aloe vera tea [bilirubin 8.4 rising to 13.8 mg/dL, ALT 935 U/L, Alk P normal], with subsequent worsening of protime and appearance of ascites, resolving 4 months after tea was stopped).
Surjushe A, Vasani R, Saple DG. (2008). Aloe vera: a short review. Indian J Dermatol. (Overview of the known contents and purported activities of aloe vera; clinical use is supported mostly by anecdotal data and results of clinical trials have been “mixed”; hepatitis listed as a side effect).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, none due to aloe vera).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; aloe vera is listed as a potential hepatotoxin but not specifically discussed).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found 15 to Aloe vera, including two cases of hepatitis; no details given).
Yang HN, Kim DJ, Kim YM, Kim BH, Sohn KM, Choi MJ, Choi YH. (2010). Aloe-induced toxic hepatitis. J Korean Med Sci. (Three women, ages 55 to 62 years, developed symptomatic liver injury 3 to 6 months after starting aloe vera extract [bilirubin 1.6, 14.6 and 0.8 mg/dL, ALT 565, 1564 and 666 U/L, Alk P 309, 211 and 298 U/L], resolving rapidly with stopping, one patient having recurrence upon reexposure: Case 2).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not aloe vera).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids; aloe vera is not discussed).
Jiménez-Encarnación E, Ríos G, Muñoz-Mirabal A, Vilá LM. Euforia-induced acute hepatitis in a patient with scleroderma. BMJ Case Rep 2012; 2012. (45 year old woman with systemic sclerosis developed jaundice 1 month after starting Euphoria, a combination herbal product whose ingredients included aloe vera, resveratrol, green tea, noni and several berries [bilirubin 17.7 mg/dL, ALT 837 U/L, Alk P 134 U/L], with slow recovery over the 18 months after stopping).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements including four publications on aloe vera).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the General population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 15 of which [16%] were attributed to HDS products, but none were listed as containing aloe vera).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury mentions that aloe vera has been associated with clinically apparent hepatotoxicity).
Teschke R, Genthner A, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2014). Herbal hepatotoxicity: analysis of cases with initially reported positive re-exposure tests. Dig Liver Dis. (Reanalysis of published cases of herbal hepatotoxicity found criteria for a positive rechallenge by the RUCAM system was met in only 21 of 34 cases reporting a positive rechallenge; one case of rechallenge with aloe vera was considered "highly probable" [Yang 2010]).
Vázquez-Fernández P, Garayoa-Roca A, Añón-Rodríguez R, Cabezas-Macián M, Serra-Desfilis MÁ, Mora-Miguel F. (2013). Aloe vera: Not always so beneficial in patients with chronic liver disease. Rev Esp Enferm Dig. (49 year old man with chronic hepatitis C and cirrhosis developed jaundice after starting aloe vera drinks for 10 days [bilirubin 21 mg/dL, ALT 93 U/L, Alk P 421 U/L], no mention of previous laboratory results or response to withdrawal of the herbal).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Lee J, Lee MS, Nam KW. (2014). Acute toxic hepatitis caused by an aloe vera preparation in a young patient: a case report with a literature review. Korean J Gastroenterol. (21 year old Korean woman developed fever and abdominal pain 1 month after starting a Herbalife preparation of aloe vera [bilirubin 1.5 mg/dL, ALT 1703 U/L, Alk P 709 U/L, white count 850/uL, platelets 57,000/uL], resolving within a month of stopping; literature review found 8 cases, 6 women, average age 47 years, all hepatocellular, 5 with jaundice, all recovered and 1 with a positive rechallenge).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products including 1 linked with aloe vera in combination with 2 other agents).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of the international regulatory framework for HDS products and the epidemiology, clinical presentation, diagnosis and cause of HDS associated liver injury with tables and discussion of the most commonly implicated agents, including aloe vera which has more than 75 different constituents and has been associated with acute hepatocellular injury with a male predominance, average age of 58 years and onset by 3 months; at least one case with a positive rechallenge has been described).
Rossi S, Navarro VJ. (2014). Herbs and liver injury: a clinical perspective. Clin Gastroenterol Hepatol. (Review of frequency, diagnosis and causes of liver injury from herbal products discusses kava, black cohosh, pyrrolizidine alkaloids, flavocoxid, glucosamine, saw palmetto, green tea, usnic acid and several proprietary herbal mixtures but not aloe vera).
Zheng EX, Navarro VJ. (2015). Liver injury from herbal, dietary, and weight loss supplements: a review. J Clin Transl Hepatol. (Review of literature on liver injury attributed to herbal weight loss supplements, does not discuss aloe vera).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of herbal associated liver injury does not discuss aloe vera specifically).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists at least 6 publications of case reports and case series implicating greater celandine in causing liver injury).
Parlati L, Voican CS, Perlemuter K, Perlemuter G. (2017). Aloe vera-induced acute liver injury: A case report and literature review. Clin Res Hepatol Gastroenterol. (68 year old Burkinabe woman was found to have abnormal liver tests but no symptoms of liver injury “several months” after starting aloe vera [ALT 196 U/L, GGT 196 U/L, bilirubin not given], which resolved within 8 weeks of stopping).
Hervás-García JV, Montané E, Serrado-Iglesias A, Ramo-Tello C. (2017). Toxic hepatitis after concomitant interferon beta and aloe vera treatment in a patient with multiple sclerosis. A case report. Neurologia. (61 year old woman with multiple sclerosis taking interferon beta-1a for 10 years and aloe vera for 3 years developed abdominal pain and fatigue and was found to have jaundice [bilirubin not given, ALT 824 U/L, Alk P 121], with rapid improvement on stopping and normal liver tests 6 months later).
Ghorbani A, Zarvandi M, Rakhshandeh H. (2019). A randomized controlled trial of a herbal compound for improving metabolic parameters in diabetic patients with uncontrolled dyslipidemia. Endocr Metab Immune Disord Drug Targets. (Among 50 patients with diabetes and dyslipidemia treated with a multiingredient herbal supplement [with aloe vera, fenugreek, black seed, psyllium, garlic and milk thistle] or placebo twice daily for 12 weeks, cholesterol, triglycerides, and HgA1c levels improved, and there was “no unwarranted effect” on serum creatinine, ALT or AST).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while none were attributed to Aloe vera).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while none were attributed to aloe vera).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62 and greater celandine [48]; there were 22 cases attributed to aloe vera which were usually mostly from Korea, Spain and the US, mostly hepatocellular [90%], with death in 10%, chronicity in 5% and recovery in 86% of cases).

## OTHER REFERENCE LINKS

1 Recent References on Aloe Vera: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Aloe+Vera+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Aloe Vera: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=aloe)